# Secnidazole

## OVERVIEW

### Introduction

Secnidazole is an orally available, broad spectrum antimicrobial agent used in the treatment of bacterial vaginosis. Secnidazole is a nitroimidazole similar to metronidazole but is used as a single dose and, unlike metronidazole, has not been linked to serum enzyme elevations during therapy or to cases of clinically apparent acute liver injury.

### Background

Secnidazole (sek nid' a zole) is an oral, broad spectrum antimicrobial that has activity against bacteria as well as several parasites and is used for therapy of suspected bacterial vaginosis. Secnidazole is a nitroimidazole similar to metronidazole and is activated intracellularly by bacterial or parasitic enzymes to a radical anion, which damages large protein molecules and DNA. Secnidazole has been available in many other countries for decades but was first approved for use in the United States in 2017 for therapy of bacterial vaginosis. Secnidazole is available in 2 gram packets of granules under the brand name Solosec. The recommended dose is a one-time dose of 2 grams, the granules sprinkled on soft food and taken within 30 minutes. Secnidazole is generally well tolerated, but side effects can include metallic or bitter taste, headache, nausea, diarrhea, abdominal pain and vulvovaginal candidiasis.

### Hepatotoxicity

Secnidazole is typically given as a single oral dose and, in follow up, de novo serum enzyme elevations occur rarely, overall rates being less than 0.5% of participants. In prelicensure studies, there were no reported cases of clinically apparent liver injury. Furthermore, despite considerable use worldwide, secnidazole has not been linked convincingly to instances of clinically apparent liver injury with jaundice.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

The cause of rare instances of serum enzyme elevations with secnidazole therapy is unknown. Its lack of hepatotoxicity probably relates to being given in a single dose. Other nitroimidazoles such as ornidazole and metronidazole have been implicated in cases of acute liver injury with jaundice, but generally with more prolonged use. Secnidazole is metabolized in the liver but has not been found to affect cytochrome P450 enzymes and has no known significant drug-drug interactions.

Drug Class: Antiinfective Agents; Gastrointestinal Agents

Other Drugs in the Subclass, Nitroimidazoles: Benznidazole, Metronidazole, Tinidazole

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Secnidazole – Generic, Solosec®

DRUG CLASS

Antiinfective Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=SECNIDAZOLE&pagesize=20&page=1)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO | MOLECULAR FORMULA | STRUCTURE
Secnidazole | 3366-95-8 | C7-H11-N3-O3

## ANNOTATED BIBLIOGRAPHY

References updated: 25 February 2020

Zimmerman HJ. Hepatic injury from the treatment of infectious and parasitic diseases. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 589-637. (Expert review of hepatotoxicity of antibiotics published in 1999; does not mention secnidazole).
Moseley RH. Antibacterial and antifungal agents. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd Edition. Amsterdam: Elsevier, 2013, pp. 463-81. (Review of hepatotoxicity of antibacterial medications; does not discuss secnidazole).
Wetzel DM, Phillips MA. Chemotherapy of protozoal infections. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 987-1000. (Textbook of pharmacology and therapeutics).
Rosenthal PJ. Antiprotozoal drugs. In, Katzung BG, Masters SB, Trevor AJ. Basic and clinical pharmacology. 12th ed. New York: McGraw Hill, 2012, pp. 915-36. (Textbook of pharmacology and therapeutics).
FDA. Drugs@FDA: FDA-Approved Drugs. Available at: https://www.accessdata.fda.gov/scripts/cder/daf/ (FDA Drug Approvals website that has product labels [package inserts], letters of approval and full FDA scientific review of the new drug application for safety and efficacy; mentions that ALT elevations arose in 3% to 6% of patients receiving secnidazole, but in a similar proportion on placebo [5%] and there were no cases with accompanying jaundice and symptoms).
Roe FJ. (1985). Safety of nitroimidazoles. Scand J Infect Dis Suppl. (Review of the safety of secnidazole and other nitroimidazoles mentions side effects of nausea, headaches, metallic taste, furred tongue, itching and skin rash, but does not discuss ALT elevations or hepatotoxicity).
Gillis JC, Wiseman LR. (1996). Secnidazole. A review of its antimicrobial activity, pharmacokinetic properties and therapeutic use in the management of protozoal infections and bacterial vaginosis. Drugs. (Review of the mechanism of action, pharmacology, clinical efficacy and tolerance of secnidazole; mentions that adverse events are generally mild and similar to those of other nitroimidazoles; no mention of ALT elevations or hepatotoxicity).
Reuben A, Koch DG, Lee WM, Acute Liver Failure Study Group. (2010). Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, but none were attributed to a nitroimidazole antibiotic).
Bohbot JM, Vicaut E, Fagnen D, Brauman M. (2010). Treatment of bacterial vaginosis: a multicenter, double-blind, double-dummy, randomised phase III study comparing secnidazole and metronidazole. Infect Dis Obstet Gynecol. (Among 577 women with suspected bacterial vaginosis treated with a single oral dose of secnidazole or a 7-day course of oral metronidazole, day 28 success rates were similar in the two groups [60.1% vs 59.5%] and adverse event rates were similar; no mention of ALT elevations or hepatotoxicity).
Pasupuleti V, Escobedo AA, Deshpande A, Thota P, Roman Y, Hernandez AV. (2014). Efficacy of 5-nitroimidazoles for the treatment of giardiasis: a systematic review of randomized controlled trials. PLoS Negl Trop Dis. (Systematic review of 30 randomized controlled trials in 3930 patients comparing nitroimidazoles including secnidazole to placebo in giardiasis; mentions that harmful outcomes were uncommon and side effects reported more commonly than with placebo included only metallic taste and headache; no mention of ALT levels or hepatotoxicity).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, none were attributed to metronidazole or other nitroimidazoles).
Hillier SL, Nyirjesy P, Waldbaum AS, Schwebke JR, Morgan FG, Adetoro NA, Braun CJ. (2017). Secnidazole treatment of bacterial vaginosis: a randomized controlled trial. Obstet Gynecol. (Among 215 women with bacterial vaginosis enrolled in a randomized control trial, clinical cure was achieved in 49% receiving 1 g and 65% receiving 2 g of secnidazole vs 19% receiving placebo; while side effects were generally mild, there were no severe adverse events, and only 1 patient had elevations in serum ALT levels).
Schwebke JR, Morgan FG, Koltun W, Nyirjesy P. (2017). A phase-3, double-blind, placebo-controlled study of the effectiveness and safety of single oral doses of secnidazole 2 g for the treatment of women with bacterial vaginosis. Am J Obstet Gynecol. (Among 189 women with bacterial vaginosis treated with a single 2 g dose of secnidazole or placebo, response rates were 53% vs 19% and adverse events were generally mild, and there were no serious adverse events and there were no “notable differences” in changes from baseline in “clinical laboratory parameters” between the two groups).
Chavoustie SE, Gersten JK, Samuel MJ, Schwebke JR. (2018). A phase 3, multicenter, prospective, open-label study to evaluate the safety of a single dose of secnidazole 2 g for the treatment of women and postmenarchal adolescent girls with bacterial vaginosis. J Womens Health (Larchmt). (Among 283 women with bacterial vaginosis treated with a single dose of secnidazole oral granules, 72.5% had an adequate clinical response and adverse events were mild-to-moderate in severity; no mention of ALT elevations or hepatotoxicity).
(2018). Secnidazole (Solosec) for bacterial vaginosis. Med Lett Drugs Ther. (Concise review of the mechanism of action, clinical efficacy, safety and costs of secnidazole shortly after its approval in the US as therapy of bacterial vaginosis; mentions side effects of headache, nausea, diarrhea, abdominal pain, vulvovaginal pruritus and dysgeusia; no mention of ALT elevations or hepatotoxicity).
Pentikis HS, Adetoro N. (2018). Two phase 1, open-label, single-dose, randomized, crossover studies to assess the pharmacokinetics, safety, and tolerability of orally administered granules of secnidazole (2 g) in healthy female volunteers under different administration conditions. Clin Pharmacol Drug Dev. (Two crossover pharmacokinetic studies of single doses of granules of secnidazole in 48 healthy controls reported adverse events including headache [46%], constipation [21%], somnolence [19%], nausea [15%] and abdominal pain [6%], and “no clinically significant changes in laboratory … findings were observed”).
Elghazaly SM, Hamam KM, Badawy MM, Yakoub Agha NA, Samy A, Abbas AM. (2019). Efficacy and safety of single dose of oral secnidazole 2 g in treatment of bacterial vaginosis: a systematic review and meta-analysis. Eur J Obstet Gynecol Reprod Biol. (Systematic review of 6 trials of secnidazole, metronidazole and ornidazole for bacterial vaginosis found similar adverse event rates, but no details given and no mention of ALT elevations or hepatotoxicity).

## OTHER REFERENCE LINKS

1 Recent References on Secnidazole: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(secnidazole/AE)%20AND%20Human%5bMH%5d%20AND%20(drug%20induced%20liver%20injury%20OR%20jaundice/CI%20OR%20bile%20duct%20diseases/CI%20OR%20liver/DE%20OR%20liver%20diseases/CI)%20AND%20(%221900%5C%5C1%5C%5C1%22%5bEDat%5d:%222999%5C%5C12%5C%5C31%22%5bEDat%5d))
2 Trials on Secnidazole: from ClinicalTrials.gov (https://www.clinicaltrials.gov/ct2/results?term=secnidazole)